# Monoclonal Antibodies

## OVERVIEW

Monoclonal antibodies are immunoglobulins that have a high degree of specificity (mono-specificity) for an antigen or epitope. Monoclonal antibodies are typically derived from a clonal expansion of antibody producing malignant human plasma cells. The initial monoclonal antibodies were created by fusing spleen cells from an immunized mouse with human or mouse myeloma cells (malignant self-perpetuating antibody producing cells), and selecting out and cloning the hybrid cells (hybridomas) that produced the desired antibody reactivity. These initial monoclonal products were mouse antibodies and were very valuable in laboratory and animal research and diagnostic assays, but were problematic as therapeutic agents because of immune reactions to the foreign mouse protein. Subsequently, production of chimeric mouse-human monoclonal antibodies and means of further “humanizing” them and producing fully human recombinant monoclonal antibodies were developed. The conventions used in nomenclature of monoclonal antibodies indicate whether they are mouse dervied (-omab), chimeric (-ximab), humanized (-zumab) or fully human (-umab).

Monoclonal antibodies have broad clinical and experimental medical uses. Many of the initial monoclonal antibodies used in clinical medicine were immunomodulatory agents with activity against specific immune cells, such as CD4 or CD3 lymphocytes, which are important in the pathogenesis of rejection after solid organ transplantation. Subsequently, monoclonal antibodies were prepared against specific cytokines (anti-cytokines), which were believed to play a role in cell and tissue damage in immunologically mediated diseases such as rheumatoid arthritis, alkylosing spondylitis, inflammatory bowel disease, multiple sclerosis and psoriasis, among others. In addition, therapeutic monoclonal antibodies were developed, aimed at blocking or inhibiting the activity of specific enzymes, cell surface transporters or signaling molecules and have been used in cancer chemotherapy and to treat severe viral infections. Use of monoclonal antibodies is currently broadening to therapy of other severe, nonmalignant conditions including asthma, atopic dermatitis, migraine headaches, hypercholesterolemia, osteoporosis, bacterial diseases (such as anthrax) and viral infections (such as COVID-19). Thus, the therapeutic monoclonal antibodies do not fall into a single class and have broad therapeutic uses. As of 2022, more than 80 therapeutic monoclonal antibodies have been approved for use in the United States.

Monoclonal antibodies are generally well tolerated. Because they are large proteins (typically 150-200,000 daltons in size) they require parenteral, often intravenous, administration. Circulating proteins are metabolized by many cells, but particularly by hepatocytes. Proteins undergo hepatic uptake by endocytosis and are either degraded or recycled to the cell surface for secretion. The hepatic metabolism of antibodies often determines their half-life. Proteins are broken down by cellular proteases into small peptides and amino acids that can used to synthesize other proteins. Metabolism of proteins does not generate toxic intermediates and, therefore, monoclonal antibodies are unlikely to induce drug induced liver injury via production of toxic metabolites. On the other hand, the peptides that are generated by the metabolism of the exogenously administered protein may ultimately be presented as foreign epitopes and generate an immune response. In addition, the primary effect of the monoclonal antibody may generate a response, either immune or otherwise, that leads to an immune mediate hepatic injury. Finally, monoclonal antibodies that suppress the immune system may cause reactivation of latent infections, including tuberculosis, herpes simplex, varicella zoster (shingles) and hepatitis B.

Among the monoclonal antibodies that have been used in clinical medicine, only a few have been linked to drug induced liver injury and, in many situations, the cause of the hepatic adverse event is often unclear. The monoclonal antibodies most clearly linked to drug induced liver injury include the antibodies to tumor necrosis factor (anti-TNF such as infliximab, adalimumab, certolizumab and golimumab) and antibodies to checkpoint proteins (anti-CTLA4 such as ipilimumab; anti-PD1 such as cemiplimab, dostarlimab, nivolumab and pembrolizumab; and anti-PD-L1 such as atezolizumab, avelumab and durvalumab) and to antibodies to B cell markers and activation signals (anti-CD20 such as rituximab, ofatumumab and tositumomab). The liver injury caused by these products is usually attributed to induction of autoimmunity or to immune modulation and reactivation of hepatitis B.

Because of their fine specificity, monoclonal antibodies can also be used to direct more conventional therapeutic agents to specific organs, tissues or cells. Several monoclonal antibody conjugates have been developed, largely in the therapy of cancer, the conjugated drug being an antineoplastic or cytotoxic agent. Five such agents are gemtuzumab ozogamicin, brentuximab vedotin, trastuzumab emtansine, inotuzumab ozogamicin and moxetumomab pasudotox. These products combine a monoclonal antibody (anti-CD33, anti-CD30, anti-HER2, anti-CD22) to a microtubule inhibitor (ozogamicin, vedotin, emtansine, pasudotox). These agents have been associated with serum enzyme elevations during therapy, and several have been linked to hepatic vascular damage, sinusoidal obstruction syndrome and nodular regenerative hyperplasia. These forms of hepatotoxicity are likely due to the conjugate (the "payload") rather than the monoclonal antibody (the targeting vehicle).

Monoclonal antibodies approved for clinical use in the United States are listed below with their brand name followed by the type of monoclonal and specific antigen targeted, the year of initial approval, likelihood score of causing liver injury, and major uses. Those monoclonal antibodies with specific chapters in LiverTox are underlined and have a link to the corresponding record. COVID-19-related monoclonal antibodies, which are typically granted Emergency Use Authorization (EUA) and are often subsequently withdrawn because of antiviral resistance, are not listed in this table but can be found in the chapter “COVID-19 Monoclonal Antibodies.”

MONOCLONAL ANTIBODIES

Underlined Generic Names link to a LiverTox chapter.

CANCER
Generic Name Brand Name | Type Antigenic Target | Year of Initial Approval | Likelihood Score† | Major Uses
Alemtuzumab Campath | Humanized CD52 | 2001 | C | Chronic lymphocytic leukemia
Amivantamab Rybrevant | Human EGF, MET | 2021 | E | Non-small cell lung cancer
Atezolizumab Tecentriq | Humanized PD-L1 | 2016 | B | Urothelial carcinoma Non-small cell lung cancer; Small cell lung cancer; Hepatocellular carcinoma
Avelumab Bavencio | Human PD-L1 | 2017 | B | Merkel cell carcinoma Urothelial carcinoma; Renal cell carcinoma
Belantamab Blenrep | Humanized BCMA | 2020; Withdrawn; In 2022 | D | Multiple myeloma
Bevacizumab Avastin | Humanized VEGF | 2004 | E | Colorectal cancer Renal, Ovarian, and Non-small cell lung cancer Macular degeneration (off lbl)
Blinatumomab Blincyto | Mouse CD3, CD19 | 2014 | E* | Acute lymphoblastic leukemia
Brentuximab Adcetris | Chimeric CD30 | 2011 | B | Hodgkin lymphoma Anaplastic large cell lymphoma
Cemiplimab Libtayo | Human PD-1 | 2018 | C | Squamous cell carcinoma; Basal cell carcinoma; Non-small cell lung cancer
Cetuximab Erbitux | Chimeric EGFR | 2004 | E | Head and neck cancer Colorectal cancer
Daratumumab Darzalex | Human CD38 | 2015 | E | Multiple myeloma
Dinutuximab Unituxin | Chimeric GD2 | 2015 | E* | Neuroblastoma
Dostarlimab Jemperli | Human PD-1 | 2021 | C | Endometrial carcinoma
Durvalumab Imfinzi | Human PD-L1 | 2017 | B | Non-small cell lung cancer Small cell lung cancer
Elotuzumab Empliciti | Humanized SLAMF7 | 2015 | D | Multiple myeloma
Enfortumab Padcev | Nectin-4 | 2019 | E* | Metastatic urothelial cancer
Gemtuzumab Mylotarg | Humanized CD33 | 2000 2017 | A | Acute myelogenous leukemia
Inotuzumab Besponsa | Humanized CD22 | 2017 | A | Acute lymphoblastic leukemia
Ipilimumab Yervoy | Human CTLA4 | 2009 | A | Malignant melanoma; Colorectal, Esophageal, Hepato-cellular and Renal cell cancer; Non-small cell lung cancer
Isatuximab Sarclisa | Chimeric CD38 | 2020 | E | Multiple myeloma
Margetuximab Margenza | Chimeric HER2 | 2020 | E | Breast cancer
Mogamulizumab Poteligeo | Humanized CCR4 | 2018 | C | Mycosis fungoides Sézary syndrome
Moxetumomab Lumoxiti | Mouse CD22 | 2018 | E* | Hairy cell leukemia
Naxitamab Danyelza | Humanized GD2 | 2020 | E | Neuroblastoma
Necitumumab Portrazza | Human EGFR | 2015 | E | Non-small cell lung cancer
Nivolumab Opdivo | Human PD-1 | 2015 | A | Malignant melanoma Colorectal, Esophageal, Hepato-cellular and Renal cell cancer Non-small cell lung cancer
Ofatumumab Arzerra | Human CD20 | 2009 | E* | Chronic lymphocytic leukemia
Olaratumab Lartruvo | Human PDGF | 2016 | E | Soft tissue sarcoma
Panitumumab Vectibix | Human EGFR | 2006 | E | Colorectal cancer
Pembrolizumab Keytruda | Humanized PD-1 | 2014 | A | Malignant melanoma Non-small cell lung cancer Advanced cervical cancer
Pertuzumab Perjeta | Humanized HER2 | 2012 | E | Breast cancer
Polatuzumab Vedotin Polivy | Human CD79b | 2019 | E* | B cell lymphomas
Ramucirumab Cyramza | Human VEGF | 2014 | E* | Gastric, non-small cell lung cancer Colorectal cancer
Rituximab Rituxan | Chimeric CD20 | 1997 | A | Chronic lymphocytic leukemia Non-Hodgkin lymphoma Rheumatoid arthritis
Sacituzumab Govitecan Trodelvy | Humanized Trop-2 | 2020 2021 2023 | E* | Triple-negative breast cancer; Urothelial cancer; Hormone receptor positive breast cancer
Tafasitamab Monjuvi | Humanized CD19 | 2020 | E | B cell malignancies, including B cell lymphoma
Teclistamab Tecvayli | Human BCMA, CD3 | 2022 | D | Multiple myeloma
Tisotumab Vedotin Tivdak | Human TF | 2021 | E | Cervical cancer
Tositumomab Bexxar | Mouse CD20 | 2003; Withdrawn | E* | Non-Hodgkin lymphoma
Trastuzumab Herceptin | Humanized HER2 | 1998 | C | Breast and gastric cancer
Trastuzumab Deruxtecam Enhertu | Humanized HER2 | 2019 | E* | Breast, gastric, and non-small cell lung cancers
Trastuzumab Emtansine Kadcyla | Humanized HER2 | 2013 | B | Breast cancer
Tremelimumab Imjudo | Human CTLA4 | 2022 | C | Hepatocellular carcinoma; Non-small cell lung cancer

AUTOIMMUNE DISEASES
Generic Name Brand Name | Type Antigenic Target | Initial Approval | Likelihood Score† | Major Uses
Adalimumab Humira | Human TNFα | 2002 | B | Inflammatory bowel disease Rheumatoid, Psoriatic arthritis Severe psoriasis
Alemtuzumab Lemtrada | Humanized CD52 | 2014 | C | Multiple sclerosis
Anifrolumab Saphnelo | Human Type 1 IFN | 2021 | E | Systemic lupus erythematosus
Axatilimab Niktimvo | Humanized CSF-1R | 2024 | E | Graft-versus-host disease
Belimumab Benlysta | Human B cell activity factor | 2011; 2020 | E | Systemic lupus erythematosus; Lupus nephritis
Brodalumab Siliq | Human IL-17A | 2017 | E | Plaque psoriasis
Canakinumab Ilaris | Human IL1β | 2009 | E* | Autoinflammatory diseases
Certolizumab Cimzia | Humanized TNFα | 2008 | E* | Inflammatory bowel disease Rheumatoid arthritis
Daclizumab Zinbryta | Humanized CD25 | 2016 | C | Multiple sclerosis
Dupilumab Dupixent | Human IL-4α | 2017 | E | Atopic dermatitis
Efalizumab Raptiva | Humanized CD11a | 2003 Withdrawn | D | Plaque psoriasis
Golimumab Simponi | Human TNFα | 2009 | E* | Inflammatory bowel disease Rheumatoid, Psoriatic arthritis
Guselkumab Tremfya | Human IL-23 | 2017 | E* | Plaque psoriasis
Infliximab Remicade | Chimeric TNFα | 1998 | A | Inflammatory bowel disease Rheumatoid arthritis Severe psoriasis
Ixekizumab Taltz | Humanized IL-17A | 2016 | E | Plaque psoriasis Psoriatic arthritis
Ocrelizumab Ocrevus | Humanized CD20 | 2017 | D | Multiple sclerosis
Omalizumab Xolair | Humanized IgE | 2003 | E | Eosinophilic asthma; Chronic idiopathic urticaria
Risankizumab Skyrizi | Humanized IL-23 | 2019 | E | Plaque psoriasis
Rituximab Rituxan | Chimeric CD20 | 1997 | A | Chronic lymphocytic leukemia Non-Hodgkin lymphoma Rheumatoid arthritis
Sarilumab Kevzara | Human IL6R | 2017 | E* | Rheumatoid arthritis
Satralizumab Enspryng | Humanized IL-6r | 2020 | E* | Neuromyelitis optica spectrum disorder
Secukinumab Cosentyx | Human IL-17A | 2015 | E* | Plaque psoriasis Psoriatic arthritis, Ankylosing spondylitis, Scalp psoriasis; Axial spondylarthritis
Siltuximab Sylvant | Chimeric IL6 | 2014 | E | Castleman disease
Tildrakizumab Ilumya | Humanized IL-23 | 2018 | E* | Plaque psoriasis
Tocilizumab Actemra | Humanized IL6R | 2010 | C | Rheumatoid arthritis; Juvenile idiopathic arthritis; Giant cell arteritis
Tralokinumab Adbry | Human IL-13 | 2021 | E | Atopic dermatitis
Ublituximab Briumvi | Chimeric CD20 | 2022 | D | Multiple sclerosis
Ustekinumab Stelara | Human IL-12, IL-23 | 2010 | E* | Plaque psoriasis Psoriatic arthritis
Vedolizumab Entyvio | Humanized Integrin α4β7 | 2014 | D | Inflammatory bowel disease

LIVER TRANSPLANTATION
Generic Name Brand Name | Type Antigenic Target | Initial Approval | Likelihood Score† | Major Uses
Basiliximab Simulect | Chimeric IL-2Rα | 1998 | E | Prevention of transplant rejection
Daclizumab Zenapax | Humanized IL-2 | 1997 Withdrawn | C | Prevention of transplant rejection
Muromonab-CD3 OKT3 | Mouse CD3 T cells | 1985; Withdrawn | E | Prevention of transplant rejection

MISCELLANEOUS
Generic Name Brand Name | Type Antigenic Target | Initial Approval | Likelihood Score† | Major Uses
Abciximab Reopro | Chimeric GpIIb/IIIa | 1993 | | Inhibition of platelet aggregation
Aducanumab Aduhelm | Human Amyloid β | 2021 | E | Alzheimer disease
Alirocumab Praluent | Human PCSK9 | 2015 | E | Hypercholesterolemia
Benralizumab Fasenra | Humanized IL5 | 2017 | E | Eosinophilic asthma
Bezlotoxumab Zinplava | Human C. difficile toxin B | 2016 | E | Prevention of recurrence of C. difficile infection
Burosumab Crysvita | Human FGF 23 | 2018 | E | X-linked Hypophosphatemia
Caplacizumab Cablivi | Humanized vWF | 2019 | E | Acquired thrombotic thrombocytopenic purpura
Crizanlizumab Adakveo | Humanized P-selectin | 2019 | E | Sickle cell disease
Donanemab Kisunla | Humanized Amyloid β | 2024 | E | Alzheimer disease
Denosumab Prolia, Zgeva | Human RANKL | 2010 | E* | Osteoporosis Bone metastases
Eculizumab Soliris | Humanized C5 | 2007 | D | Paroxysmal nocturnal hemoglobinuria
Emapalumab Gamifant | Human Interferon Gamma | 2018 | E | Hemophagocytic lymphohistiocytosis
Emicizumab Hemlibra | Humanized Factor IXa & X | 2017 | E | Hemophilia A
Eptinezumab Vyepti | Humanized CGRP | 2019 | E | Migraine headache
Erenumab Aimovig | Human CGRP | 2018 | E | Migraine headache
Evinacumab Evkeeza | Human ANGPTL3 | 2021 | E | Hypercholesterolemia
Evolocumab Repatha | Human PCSK9 | 2015 | E | Hypercholesterolemia
Fremanezumab Ajovy | Humanized CGRP | 2018 | E | Migraine headache
Galcanezumab Emgality | Humanized CGRP | 2018 | E | Migraine headache
Ibalizumab Trogarzo | Humanized CD4 | 2018 | E | HIV infection
Inebilizumab Uplizna | Humanized CD19 | 2020 | E | Neuromyelitis optica spectrum disorder
Lanadelumab Takhzyro | Human Kallikrein | 2018 | E | Hereditary angioneurotic edema
Lecanemab Leqembi | Human Amyloid β | 2023 | E | Alzheimer disease
Mepolizumab Nucala | Humanized IL15 | 2015 | E | Eosinophilic asthma Hypereosinophilic syndrome
Natalizumab Tysabri | Humanized Integrin α4β7 | 2004 | B | Multiple sclerosis Inflammatory bowel disease
Obiltoxaximab Anthim | Chimeric Anthrax toxin | 2016 | E | Inhalational anthrax
Omalizumab Xolair | Humanized IgE | 2003 | E | Eosinophilic asthma; Chronic idiopathic urticaria
Palivizumab Synagis | Humanized RSV fusion protein | 1998 | E | Respiratory syncytial virus infection
Ranibizumab Lucentis | Humanized VEGF-A | 2006 | E | Macular degeneration
Ravulizumab Ultomiris | Humanized Complement C5 | 2018 | E* | Paroxysmal noctural hemoglobinuria
Raxibacumab | Human Anthrax toxin | 2012 | E | Inhalational anthrax
REGN-EB3 [Atoltivimab, Maftivimab, Odesivimab] Inmazeb | Human Ebolavirus glycoprotein | 2020 | E | Ebolavirus infection
Reslizumab Cinqair | Humanized IL5 | 2016 | E | Eosinophilic asthma
Romosozumab Evenity | Humanized Sclerostin | 2019 | E | Osteoporosis
Teplizumab Tzield | Humanized CD3 | 2022 | E | Diabetes
Teprotumumab Tepezza | Human IGF1R | 2019 | E | Graves ophthalmopathy
Tezepelumab Tezspire | Human TSLP | 2021 | E | Asthma

† Likelihood Score indicates the likelihood of association with drug induced liver injury,

based upon the known potential of the drug to cause such injury.

Updated: April 9, 2025